# Eugenol (Clove Oil)

## OVERVIEW

### Introduction

Eugenol, also called clove oil, is an aromatic oil extracted from cloves that is used widely as a flavoring for foods and teas and as an herbal oil used topically to treat toothache and more rarely to be taken orally to treat gastrointestinal and respiratory complaints. Eugenol in therapeutic doses has not been implicated in causing serum enzyme elevations or clinically apparent liver injury, but ingestions of high doses, as with an overdose, can cause severe liver injury.

### Background

Eugenol (ue gen’ ol) is the major constituent [70% to 90%] in the aromatic oil extract from cloves (Syzygium aromaticum), a spice widely used as a flavoring for meats, stews, cakes and teas. Eugenol is also found in lower concentrations in cinnamon and other aromatic spices. The clove is native to the Moluccas, a chain of small islands that are now part of Indonesia and were formerly known as the Spice Islands. Cloves are now grown in several tropical regions and the spice sold as intact flower buds or as a ground powder. Eugenol is the most abundant ingredient in clove oil and is thought to be responsible for its aromatic as well as both beneficial and harmful effects. In vitro, eugenol has been shown to have antibacterial, antifungal, antioxidant and antineoplastic activity. Clove oils including eugenol have been claimed to have gentle local anesthetic and antiseptic activities and previously were commonly used in dentistry. Eugenol and clove extracts have also been purposed to be beneficial for gastrointestinal complaints such as nausea, diarrhea, abdominal pain and for cough, phlegm and chest congestion (as an expectorant). However, there are no convincing data to support the efficacy for any of these conditions, and neither eugenol or other clove extracts have been approved for use in any medical condition in the United States. Nevertheless, clove extracts are found in many topical creams, lotions and bath oils and occasionally in toothpaste for its possible effect in alleviating toothache or painful gums and in electronic cigarette refills. Vials of clove oil are available in health food and ethnic grocery stores and on the internet. Clove oil is advertised as having powerful antioxidant benefits and being useful for toothache, cleaning teeth and freshening of the breath. Clove cigarettes consisting of 60% to 70% tobacco and 30% to 40% cloves were imported from Indonesia and became popular in the United States in the early 1980’s when they were ultimately linked to a dozen cases of severe lung injury and banned from sale in many states. In addition, eugenol in higher doses has been used as an “organic” insecticide in households and gardens. Thus, eugenol used in low doses appears to have few side effects other than local irritation, rare allergic reactions and contact dermatitis, while exposure or ingestion of a large amounts, as in overdose, can result in tissue injury and a syndrome of acute onset of seizures, coma and damage to the liver and kidneys.

### Hepatotoxicity

The low concentrations of eugenol and clove extracts used topically and in herbal products have not been convincingly linked to instances of liver injury, either in the form of serum enzyme elevations or clinically apparent liver injury. In high doses, however, eugenol appears to be a direct cytotoxin and several instances of severe acute liver and kidney injury have been reported after accidental overdose of eugenol containing herbal products, largely in children. Overdoses have been marked by the onset of agitation, decrease in consciousness and coma arising within hours on ingestion (10-30 mL of clove oil). There is typically an accompanying acidosis, respiratory depression and severe hypoglycemia requiring ventilation and intravenous glucose. Liver injury arises 12 to 24 hours after ingestion with marked elevations in serum aminotransferase levels and early coagulation abnormalities. Signs of hepatic failure arise rapidly, and jaundice can develop and deepen. The overall clinical presentation is typical of acute hepatic necrosis and similar to that of acetaminophen, iron or copper overdose. The liver injury generally worsens for several days but then rapidly improves and ultimately resolves within 1 to 3 weeks. Renal dysfunction may also occur but rarely requires intervention or dialysis. Long term injury or effects have not been described. Cases described in the literature have been in infants who swallowed clove oil being used by parents.

Likelihood score: C[H] (probable cause of clinically apparent liver injury in overdoses).

### Mechanism of Injury

In high concentrations, eugenol has cytotoxic activity both in vitro and in vivo, characteristics [along with its aromatic qualities] that support its use as an insecticide. Thus, liver injury from eugenol is likely direct hepatotoxicity.

### Outcome and Management

The acute liver injury of eugenol overdose presents clinically with acute hepatic necrosis, a pattern similar to that of acetaminophen hepatotoxicity. For these reasons, N-acetyl cysteamine has been used to treat patients with eugenol or clove oil overdose. While not proven to be effective for eugenol overdose in humans, it has been shown to be effective in preventing hepatic injury in animal models. Also important in management is careful attention to details of medical management including prevention of hypoglycemia and maintenance of electrolyte balance and respiratory support. If patients present early, use of activated charcoal or emetics may be useful.

Other Names: Clove oil

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Eugenol – Generic (OTC Products)

DRUG CLASS

Herbal and Dietary Supplements

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/251.html) [Clove Oil]

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Eugenol | 97-53-0 (https://pubchem.ncbi.nlm.nih.gov/substance/134970633) | C10-H12-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 15 October 2019

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbals are discussed, including comfrey, germander, chaparral leaf, skullcap and valerian, but not eugenol or clove oil).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; clove oil is not discussed).
Clove. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc., 2007: pp. 201-4. (Compilation of short monographs on herbal medications and dietary supplements).
Barkin ME, Boyd JP, Cohen S. (1984). Acute allergic reaction to eugenol. Oral Surg Oral Med Oral Pathol. (Case report of allergic reaction to a temporary zinc oxide-eugenol dental restoration that required corticosteroid therapy and recurred after exposure to a similar dental sealer).
Centers for Disease Control (CDC). (1985). Illnesses possibly associated with smoking clove cigarettes. MMWR Morb Mortal Wkly Rep. (Initial report of 2 cases of sudden onset of severe lung injury in previously healthy California teenagers shortly after smoking clove cigarettes, initially thought to be bacterial pneumonia but not responding to antibiotics while reversing rapidly with corticosteroid therapy).
(1988). Evaluation of the health hazard of clove cigarettes. Council on Scientific Affairs. JAMA. (Report from an expert committee of the American Medical Association summarizes the chemistry, metabolism, toxicity and clinical evidence of acute pulmonary toxicity from clove cigarettes based upon review of 10 cases from the literature; 8 males, 2 females, ages 11 to 29, 7 from California, with history of smoking clove cigarettes within hours of presentation with severe lung injury, with two fatalities).
American Academy of Pediatrics Committee on Substance Abuse. (1991). Hazards of clove cigarettes. Pediatrics. (Brief statement from a committee on substance abuse of American Academy of Pediatrics on the potential of clove cigarettes to cause severe liver injury).
Thompson DC, Constantin-Teodosiu D, Moldéus P. (1991). Metabolism and cytotoxicity of eugenol in isolated rat hepatocytes. Chem Biol Interact. (Exposure of rat hepatocytes to eugenol caused glutathione depletion and cell death within hours, effects that were dose-dependent and were prevented by N-acetylcysteine).
Mizutani T, Satoh K, Nomura H, Nakanishi K. (1991). Hepatotoxicity of eugenol in mice depleted of glutathione by treatment with DL-buthionine sulfoximine. Res Commun Chem Pathol Pharmacol. (Mice treated with eugenol developed hepatotoxicity only when pretreated with inhibitors of glutathione synthesis).
Brown SA, Biggerstaff J, Savidge GF. (1992). Disseminated intravascular coagulation and hepatocellular necrosis due to clove oil. Blood Coagul Fibrinolysis. (2 year old boy ingested 10 mL of clove oil and rapidly developed stupor, seizures, hypoglycemia, acidosis and coagulopathy with liver injury arising a day later [bilirubin 2.4 rising to 4.0 mg/dL, ALT 1549 to 5293 U/L, Alk P 418 to 587 U/L], with hepatic encephalopathy and renal dysfunction ultimately resolving within the next 3 weeks).
Hartnoll G, Moore D, Douek D. (1993). Near fatal ingestion of oil of cloves. Arch Dis Child. (2 year old boy with acute liver failure after ingestion of clove oil [peak INR 6.51] treated with multiple coagulation factors; probably the same case as described by Brown et al [1992]).
Sarrami N, Pemberton MN, Thornhill MH, Theaker ED. (2002). Adverse reactions associated with the use of eugenol in dentistry. Br Dent J. (Two cases of painful gums and oral ulcers arising days to weeks after application of eugenol impregnated temporary dental dressings, resolving after removal; both patients later having positive skin-patch tests to eugenol).
Eisen JS, Koren G, Juurlink DN, Ng VL. (2004). N-acetylcysteine for the treatment of clove oil-induced fulminant hepatic failure. J Toxicol Clin Toxicol. (3 month old girl ingested 8 mL of clove oil and rapidly developed obtundation followed the next day by rises in ALT [peak 8761 U/L], AST [peak >10,000 U/L] and INR [peak 3.86], accompanied by acidosis and hypoglycemia, treated with fresh frozen plasma and N-acetylcysteine with recovery over the next few days).
Janes SE, Price CS, Thomas D. (2005). Essential oil poisoning: N-acetylcysteine for eugenol-induced hepatic failure and analysis of a national database. Eur J Pediatr. (15 month old boy developed agitation 1 hour after ingesting 10-20 mL of clove oil requiring ventilation and followed 15 hours later by marked rises in ALT [peak ~13,000 U/L] and INR [peak 2.0] with renal dysfunction [peak creatinine 11.8/xx] and acidosis [pH nadir 7.33], treated with vitamin K and N-acetylcysteine with resolution over the next 8 days).
Deshpande A, Verma S, Macwan C. (2014). Allergic reaction associated with the use of eugenol containing dental cement in a young child. Austin Journal of Dentistry. (6 year old girl developed pain and allergic rash around a temporary dental restoration using zinc oxide-eugenol cement, resolving on removal).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, no cases were attributed to clove oil).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver toxicity attributed to HDS products, does not list or mention clove oil or eugenol).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or mention clove oil or eugenol).
Fetterman JL, Weisbrod RM, Feng B, Bastin R, Tuttle ST, Holbrook M, Baker G, et al. (2018). Flavorings in tobacco products induce endothelial cell dysfunction. Arterioscler Thromb Vasc Biol. (Various flavoring compounds including eugenol decrease nitric oxide production by venous endothelial cells and induce cell death in dose dependent manner).
Behar RZ, Luo W, McWhirter KJ, Pankow JF, Talbot P. (2018). Analytical and toxicological evaluation of flavor chemicals in electronic cigarette refill fluids. Sci Rep. (Chemical analysis of 39 commercial e-cigarette refill cartridges found 12 flavoring chemicals in concentrations above 1 mg/mL, eugenol being found in 6 [15%] in concentrations of 0.6 to 6 mg/mL).
Navarro Triviño FJ, Cuenca-Barrales C, Ruiz-Villaverde R. (2019). Eugenol allergy mimicking recurrent aphthous stomatitis and burning mouth syndrome. Contact Dermatitis. (77 year old woman developed recurrent oral ulcers and burning mouth syndrome shortly after placement of a dental prosthesis using eugenol containing cement which persisted for 10 months, resolving when the prosthesis was removed).
Bui TNPT, Mose KF, Andersen F. (2019). Eugenol allergy mimicking burning mouth syndrome. Contact Dermatitis. (68 year old woman with burning mouth syndrome for 2 years and positive patch test to eugenol mentioned that she used a eugenol mouthwash and chewed cloves daily, her symptoms improving with discontinuation of oral use of eugenol and cloves).

## OTHER REFERENCE LINKS

1 Recent References on Eugenol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/pubmed?cmd=search&pubmedfilters=true&term=(Eugenol/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900/1/1%22%5bEDat%5d:%222999/12/31%22%5bEDat%5d))
2 Trials on Eugenol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Eugenol)